# Romidepsin

## OVERVIEW

### Introduction

Romidepsin is an intravenously administered histone deacetylase inhibitor and antineoplastic agent that is approved for use in refractory or relapsed cutaneous and peripheral T cell lymphomas. Romidepsin is associated with modest rate of minor serum enzyme elevations during therapy but has not been linked to cases of clinically apparent liver injury, although it has been reported to cause reactivation of hepatitis B.

### Background

Romidepsin (roe" mi dep' sin) is an intravenously administered antineoplastic agent which acts by inhibition of histone deacetylases, thereby preventing removal of acetyl groups from histones. The accrual of acetyl groups on histones causes cell cycle arrest and apoptotic cell death. Malignant cells and particularly malignant T cells are particularly sensitive to the effects of inhibition of histone deacetylases. Romidepsin was initially isolated from a bacterium Chromobacterium violaceum and found to have antineoplastic activity. Elucidation of its molecular structure and analysis of its in vitro effects demonstrated that it was a histone deacetylase. Romidepsin has been evaluated as therapy of several malignancies and found to have greatest activity in T cell lymphomas. Romidepsin was approved for use in the United States in 2009 as monotherapy for refractory or relapsing cutaneous T cell lymphoma (CTCL) and indications were expanded in 2011 to include refractory or relapsing peripheral T cell lymphoma (PTCL). Romidepsin is available as a powder for reconstitution in 10 mg vials under the commercial name Istodax. The recommended dose is 14 mg/m^2^ given intravenously on days 1, 8 and 15 of a 28 day cycle. Side effects are common, but usually mild-to-moderate in severity, and include nausea, fatigue, fever, anemia, neutropenia, thrombocytopenia, constipation and rash. Side effects lead to early discontinuation in up to 15% of patients. Severe adverse events can include marked neutropenia, thrombocytopenia, serious infections, sepsis, tumor lysis syndrome and cardiac arrhythmias.

### Hepatotoxicity

In clinical trials of romidepsin in patients with CTLC and PTLC, the rates of serum enzyme elevations during therapy ranged from 7% to 20%, but the abnormalities were usually transient and mild and did not require dose modifications. Serum ALT elevations above 5 times ULN occurred in 6% of patients. In the preregistration clinical trials of romidepsin, there were no reports of hepatitis, jaundice or clinically apparent liver injury among the treated subjects. Romidepsin has had limited clinical use, but there is no evidence that it is associated with significant liver injury.

Romidepsin also has immunomodulatory activities and has been reported to cause reactivation of latent DNA viruses including Epstein-Barr, varicella zoster and hepatitis B virus. Reactivation of hepatitis B occurred in a patient who was initially negative for HBsAg, but reactive for anti-HBc and anti-HBs. Nevertheless, the clinical features of hepatitis B reactivation were mild and responded to oral antiviral therapy. In patients with EBV associated lymphoma, romidepsin has been associated with severe reactivation of EBV infection and acute hepatitis that can be severe and even fatal.

Likelihood score: C (probable cause of clinically apparent liver injury, which can be due to reactivation of hepatitis B or EBV infection).

### Mechanism of Injury

The reason why romidepsin might cause serum enzyme elevations is not known, but may be a direct toxicity to hepatocytes caused by inhibition of histone deacetylase or other enzyme activities. Romidepsin is metabolized in the liver by cytochrome P450 system, predominantly CYP 3A4 and is susceptible to drug-drug interactions. Reactivation of hepatitis B and EBV is likely due to the immunomodulatory actions of romidepsin.

### Outcome and Management

Serum enzyme elevations during romidepsin therapy are usually mild and rarely dose limiting. Romidepsin should be held if ALT or AST values rise above 5 times the ULN and should be permanently discontinued if elevations exceed 20 times the ULN, or with the appearance of jaundice or symptoms of liver injury. There is no known cross sensitivity to hepatic injury among the different histone deacetylase inhibitors. Patients who are to receive romidepsin should be screened for evidence of hepatitis B and monitored carefully or given prophylaxis against HBV reactivation if they have evidence on ongoing or previous infection. Patients with active EBV infection should be treated with caution and with prophylaxis against reactivation.

Drug Class: Antineoplastic Agents, Histone Deacetylase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Romidepsin – Istodax®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Romidepsin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Romidepsin | 128517-07-7 | C24-H36-N4-O6-S2

## ANNOTATED BIBLIOGRAPHY

References updated: 25 September 2020

Abbreviation: PTCL, peripheral T-cell lymphoma.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of histone deacetylase inhibitors).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 549-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; does not discuss romidepsin).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Inhibitors of histone deacetylase. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, p. 1230. (Textbook of pharmacology and therapeutics).
Ritchie D, Piekarz RL, Blombery P, Karai LJ, Pittaluga S, Jaffe ES, Raffeld M, et al. (2009). Reactivation of DNA viruses in association with histone deacetylase inhibitor therapy: a case series report. Haematologica. (Adult woman with PTCL refractory to conventional therapy received romidepsin and developed hepatitis after 11 cycles [bilirubin not given, ALT 226 U/L, HBsAg and HBeAg positive, IgM anti-HBc positive and HBV DNA 7.9 log10 copies/mL], biopsy showing moderate inflammation, and hepatitis resolving with entecavir therapy, but no follow up provided).
Piekarz RL, Frye R, Turner M, Wright JJ, Allen SL, Kirschbaum MH, Zain J, et al. (2009). Phase II multi-institutional trial of the histone deacetylase inhibitor romidepsin as monotherapy for patients with cutaneous T-cell lymphoma. J Clin Oncol. (Among 71 patients with CTCL treated with romidepsin, the overall response rate was 34% and common side effects were nausea [52%], fatigue [41%]. vomiting [20%], anorexia [21%], leukopenia [31%], thrombocytopenia [39%], anemia [37%], infection [54%] and ALT or AST elevations [13%], but there were no episodes of clinically apparent liver injury).
Whittaker SJ, Demierre MF, Kim EJ, Rook AH, Lerner A, Duvic M, Scarisbrick J, et al. (2010). Final results from a multicenter, international, pivotal study of romidepsin in refractory cutaneous T-cell lymphoma. J Clin Oncol. (Among 96 patients with CTCL treated with romidepsin, the overall response rate was 34% and adverse events were common, including gastrointestinal disturbance, fatigue, prolonged QTc, fever, tumor lysis syndrome and cardiac arrhythmias, but no one had ALT or AST elevations above 5 times ULN).
Guan P, Fang H. (2010). Clinical development of histone deacetylase inhibitor romidepsin. Drug Discov Ther. (Review of the potential of histone deacetylase inhibitors as cancer chemotherapeutic agents states that romidepsin has a “tolerable toxicity profile”).
(2010). Romidepsin (Istodax) for cutaneous T-cell lymphoma. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety, drug-drug interactions and costs of romidepsin therapy shortly after its approval in the US as monotherapy for refractory or relapsed CTCL).
Cheson BD, Horwitz SM, Weisenburger DD. (2011). Peripheral T-cell lymphomas: diagnosis and treatment options. Proceedings from a live roundtable, August 17, 2011, Kauai, Hawaii. Clin Adv Hematol Oncol. (Summary of the current status of the clinical features, natural history, diagnosis and management of PTCL).
Jones SF, Infante JR, Spigel DR, Peacock NW, Thompson DS, Greco FA, McCulloch W, et al. (2012). Phase 1 results from a study of romidepsin in combination with gemcitabine in patients with advanced solid tumors. Cancer Invest. (Dose finding study of romidepsin and gemcitabine used in combination with paclitaxel for breast cancer, with cisplatin for NSCLC and with carboplatin for ovarian cancer; combinations that showed synergy in animal models).
Kim M, Thompson LA, Wenger SD, O'Bryant CL. (2012). Romidepsin: a histone deacetylase inhibitor for refractory cutaneous T-cell lymphoma. Ann Pharmacother. (Review of the pharmacology, clinically efficacy and safety of romidepsin mentions ALT or AST elevations occurred in 7-20% of patients which are above 5 times ULN in 6%).
Coiffier B, Pro B, Prince HM, Foss F, Sokol L, Greenwood M, Caballero D, Borchmann P, et al. (2012). Results from a pivotal, open-label, phase II study of romidepsin in relapsed or refractory peripheral T-cell lymphoma after prior systemic therapy. J Clin Oncol. (Among 130 patients with PTCL treated with romidepsin, the overall response rate was 25% and the most frequent serious adverse events were thrombocytopenia [24%], neutropenia [20%], and infections [19%]; no mention of ALT elevations or hepatotoxicity).
Coiffier B, Pro B, Prince HM, Foss F, Sokol L, Greenwood M, Caballero D, et al. (2014). Romidepsin for the treatment of relapsed/refractory peripheral T-cell lymphoma: pivotal study update demonstrates durable responses. J Hematol Oncol. (Among 130 patients with PTCL treated with romidepsin, the overall response rate was 25% and adverse event rates decreased with long term therapy; no mention of ALT elevations or hepatotoxicity).
Foss F, Coiffier B, Horwitz S, Pro B, Prince HM, Sokol L, Greenwood M, et al. (2014). Tolerability to romidepsin in patients with relapsed/refractory T-cell lymphoma. Biomark Res. (Combined analysis of the adverse events of romidepsin in trials of therapy in PTCL and CTCL focusing on gastrointestinal intolerance, cytopenias and serious infections; no mention of ALT elevations or hepatotoxicity).
Dupuis J, Morschhauser F, Ghesquières H, Tilly H, Casasnovas O, Thieblemont C, Ribrag V, et al. (2015). Combination of romidepsin with cyclophosphamide, doxorubicin, vincristine, and prednisone in previously untreated patients with peripheral T-cell lymphoma: a non-randomised, phase 1b/2 study. Lancet Haematol. (Among 37 patients with PTCL treated with CHOP and romidepsin, 89% of patients had some degree of hematologic toxicity, serious adverse events occurred in 68%, and ALT or AST elevations arose in 49% which were above 5 times ULN in 8%).
Zinzani PL, Pellegrini C, Cerciello G, Monaco F, Volpetti S, Peli A, Angelucci E, et al. (2016). Romidepsin in relapsed/refractory T-cell lymphomas: Italian experience and results of a named patient program. Leuk Lymphoma. (Among 33 patients with refractory or relapsed T cell lymphomas treated with romidepsin, the overall response rate was 24% and adverse events led to early stopping in 23%; but no mention of ALT elevations or hepatotoxicity).
Pellegrini C, Dodero A, Chiappella A, Monaco F, Degl'Innocenti D, Salvi F, Vitolo U, et al., Italian Lymphoma Foundation. (2016). (Fondazione Italiana Linfomi Onlus, FIL). A phase II study on the role of gemcitabine plus romidepsin (GEMRO regimen) in the treatment of relapsed/refractory peripheral T-cell lymphoma patients. J Hematol Oncol. (Among 20 patients with refractory or relapsed PTCL treated with romidepsin and gemcitabine, the overall response rate was 30% and adverse events were frequent including ALT or AST elevations in 20%, which were above 5 times ULN in 15%; no mention of clinically apparent liver injury).
Kim SJ, Kim JH, Ki CS, Ko YH, Kim JS, Kim WS. (2016). Epstein-Barr virus reactivation in extranodal natural killer/T-cell lymphoma patients: a previously unrecognized serious adverse event in a pilot study with romidepsin. Ann Oncol. (Among 5 patients with extranodal NK T cell lymphoma treated with romidepsin, 3 developed evidence of EBV reactivation accompanied by elevations in AST [460-2600 U/L] and bilirubin [4-9 mg/dL], one dying of acute liver failure).
Bringhen S, De Wit E, Dimopoulos MA. (2017). New agents in multiple myeloma: an examination of safety profiles. Clin Lymphoma Myeloma Leuk. (Review of the safety profiles and adverse events of newer drugs for multiple myeloma including the histone deacetylase inhibitors – romidepsin, vorinostat and panobinostat, mentions that ALT elevations above 5 times ULN occur in 8% of patients treated with romidepsin but no mention of ALT elevations or hepatotoxicity with vorinostat or panobinostat).
Moskowitz AJ, Horwitz SM. (2017). Targeting histone deacetylases in T-cell lymphoma. Leuk Lymphoma. (Extensive review of the mechanism of action, classification, clinical efficacy and safety of histone deacetylase inhibitors in T-cell lymphomas, mentions that romidepsin is a parenterally administered bicyclic peptide that is approved for use in refractory or relapsed cutaneous and peripheral T cell lymphoma, common adverse effects of which are nausea, fatigue, anemia, thrombocytopenia, neutropenia, infections, anorexia, hyperglycemia, constipation, pruritus, and ALT elevations).
Duvic M, Bates SE, Piekarz R, Eisch R, Kim YH, Lerner A, Robak T, et al. (2018). Responses to romidepsin in patients with cutaneous T-cell lymphoma and prior treatment with systemic chemotherapy. Leuk Lymphoma. (Retrospective analysis of efficacy and safety of romidepsin in 96 previously treated patients with cutaneous T-cell lymphoma, found that severe adverse events were more frequent in those with previous treatment; no mention of ALT levels or hepatotoxicity).
Shimony S, Horowitz N, Ribakovsky E, Rozovski U, Avigdor A, Zloto K, Berger T, et al. (2019). Romidepsin treatment for relapsed or refractory peripheral and cutaneous T-cell lymphoma: Real-life data from a national multicenter observational study. Hematol Oncol. (Among 53 patients with cutaneous or peripheral T cell lymphoma treated with romidepsin at 5 centers in Israel between 2013 and 2018, adverse events were frequent including anemia [86%], thrombocytopenia [69%], neutropenia [68%] and infections [36%], but there was no mention of ALT elevations or hepatotoxicity).
Shah RR. (2019). Safety and tolerability of histone deacetylase (HDAC) inhibitors in oncology. Drug Saf. (Review of the safety of histone deacetylase inhibitors approved for use in the US mentions that elevations in serum aminotransferase levels have been reported during therpy with romidepsin, panobinostat and belinostat but not with vorinostat and there have been no reports of clinically apparent hepatotoxicity, except for a single case of hepatic failure arising during a clinical trial of belinostat).

## OTHER REFERENCE LINKS

1 Recent References on Romidepsin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Romidepsin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2 Trials on Romidepsin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Romidepsin)